# Dimethyl Fumarate

## OVERVIEW

### Introduction

Dimethyl fumarate, monomethyl fumarate and diroximel fumarate are antiinflammatory and immunomodulatory agents that are used to treat relapsing multiple sclerosis and have similar beneficial as well as adverse effects. Dimethyl fumarate is associated with low rates of transient serum enzyme elevations during treatment, and with rare instances of clinically apparent liver injury with jaundice. There is limited clinical experience with monomethyl and diroximel fumarate and the risk of liver injury with their use remains unclear.

### Background

Dimethyl fumarate (dye meth' il fue' ma rate) is a methylated, unsaturated dicarboxylic acid which has distinctive antiinflammatory and immunomodulatory activities, both in vitro and in vivo. Its mechanism of action is believed to be via activation of the nuclear factor E2-related factor (NrF2) pathway, which is important in inducing antioxidant responses and enhancing antiinflammatory cytokines. Dimethyl fumarate is a prodrug and is rapidly metabolized to monomethyl fumarate, the active metabolite which is the only form detected in serum. Because of its immunomodulatory activity, dimethyl fumarate has been evaluated in psoriasis, sarcoidosis, and alopecia areata with promising results, but has been approved in the United States only for multiple sclerosis. In several large, randomized controlled trials, dimethyl fumarate was shown to reduce relapse rates and improve neuroradiologic outcomes in adult patients with relapsing-remitting multiple sclerosis. Dimethyl fumarate was approved for use in relapsing multiple sclerosis in the United States in 2013 and is now available in delayed release capsules of 120 and 240 mg under the brand name Tecfidera. The recommended dose is 120 mg twice daily for 7 days, followed by a maintenance dose of 240 mg twice daily. Common side effects are flushing (25% to 50%), gastrointestinal symptoms of nausea, diarrhea or abdominal pain (10% to 60%), dizziness, erythema (5%) and skin rash (9%). Rare but potentially severe adverse events include anaphylaxis, angioedema, severe lymphopenia, herpes zoster, liver injury, and progressive multifocal leukoencephalopathy (PML).

Diroximel fumarate (dye rox’ I mel fue’ ma rate), like dimethyl fumarate, is a prodrug of monomethyl fumarate and appears to have similar antiinflammatory and immunomodulatory activities as the dimethyl form. It was approved for use in adults with relapsing forms of multiple sclerosis in the United States in 2019 based largely upon bioequivalence studies with dimethyl fumarate, blood levels of the active metabolite (monomethyl fumarate) of both prodrugs being similar. Diroximel fumarate is available in delayed release capsules of 231 mg under the brand name Vumerity. The recommended dose is 231 mg twice daily for 7 days followed by a maintenance dose of 462 mg twice daily. The side effect profile of diroximel fumarate is similar to that of dimethyl fumarate, although the frequency of some gastrointestinal adverse reactions may be less and overall tolerance appears to be better.

Monomethyl fumarate (mon” oh meth’ il fue’ ma rate) has similar antiinflammatory and immunomodulatory activities as dimethyl fumarate, it being the active metabolite of the dimethylated form. Monomethyl fumarate was approved for use in adults with relapsing forms of multiple sclerosis in the United States in 2020 based upon studies showing bioequivalence with dimethyl fumarate. Both drugs lead to similar blood levels of the active metabolite (monomethyl fumarate). Monomethyl fumarate is available in delayed release capsules of 95 mg under the brand name Bafiertam. The recommended dose is 95 mg twice daily for 7 days followed by a maintenance dose of 190 mg twice daily. The side effect profile is similar to that of dimethyl fumarate, although the frequency of some gastrointestinal side effects may be less.

### Hepatotoxicity

In large randomized controlled trials of dimethyl fumarate in patients with psoriasis and multiple sclerosis, serum ALT elevations were frequent, occurring in up to 25% of patients. The elevations, however, were generally mild-to-moderate and resolved rapidly even without dose modification. Elevations above 3 times ULN were reported in 6% of dimethyl fumarate compared to 3% to 6% of placebo recipients. The enzyme elevations were usually transient and not associated with symptoms or jaundice, requiring drug discontinuation in less than 1% of patients. No cases of acute hepatitis or clinically apparent liver injury were reported in the preregistration trials of methyl fumarate. Despite this, several cases of clinically apparent liver injury with jaundice were reported within 2 to 3 years of its approval and more widescale use. Most cases occurred within 2 to 3 months of starting dimethyl fumarate but some instances with more prolonged latency were reported. The typical case presented with acute hepatitis like features, marked increases in serum aminotransferase levels, and only modest alkaline phosphatase elevations. Immunoallergic features and autoantibodies were not frequent and all patients recovered upon stopping the medication with no reported instances of chronic injury or hepatic failure.

Cases of clinically apparent liver injury have not been reported with diroximel or monomethyl fumarate but the clinical experience with these agents has been limited. Because the side effect profiles of these three pro-drugs of monomethyl fumarate are similar, it is suspected that all three are rare causes of clinically apparent liver injury.

Likelihood score for dimethyl fumarate: C (probable rare cause of clinically apparent liver injury).

Likelihood score for diroximel fumarate: E* (unproven but suspected rare cause of clinically apparent liver injury).

Likelihood score for monomethyl fumarate: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which dimethyl fumarate causes liver injury is not known but is likely to be idiosyncratic. It is extensively metabolized by serum and tissue esterases to monomethyl fumarate, which is further metabolized in the liver to fumarate which enters the tricarboxylic acid (TCA) cycle. Dimethyl fumarate metabolism is independent of the cytochrome P450 system.

### Outcome and Management

While chronic therapy with a fumarate can be associated with mild-to-moderate serum aminotransferase elevations, these three agents have been linked only rarely to cases of clinically apparent liver injury. Current recommendations are to assess routine liver tests before starting treatment and then again “as clinically indicated” during therapy. Patients with serum aminotransferase elevations accompanied by symptoms or jaundice (bilirubin 2.5 mg/dL or above) should have therapy discontinued or at least interrupted until the nature of the liver injury is clarified. There is reason to suspect that there is cross sensitivity of the hepatic injury from dimethyl fumarate and either diroximel or monomethyl fumarate, but no reason to suspect cross sensitivity to hepatic injury with other agents used to treat multiple sclerosis.

Drug Class: Multiple Sclerosis Agents

## CASE REPORT

### Case 1. Acute hepatitis arising after 4 weeks of dimethyl fumarate therapy.(1)

A 26 year old woman with multiple sclerosis was found to have de novo elevations in serum aminotransferase levels (ALT 284 U/L) 4 weeks after starting dimethyl fumarate (120 mg twice daily). The drug was stopped, but over the next 4 weeks she developed fatigue, nausea, abdominal pain and dark urine followed by jaundice. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis and was not taking other medications. On examination, she was jaundiced, but had no rash, fever or signs of hepatic failure. Serum bilirubin was 9.0 mg/dL, ALT 1256 U/L, alkaline phosphatase 133 U/L and INR 1.58. Other causes of acute liver injury were excluded. Tests for hepatitis A, B, C and E were negative as were autoantibodies. Imaging of the liver showed no evidence of biliary obstruction. A liver biopsy showed acute hepatitis with bridging necrosis. There was bile duct injury but no duct loss, hepatic steatosis or fibrosis. During the next month, symptoms resolved and liver tests decreased towards the normal range. When seen a year later all blood tests were normal and she was being managed on glatiramer acetate.

#### Key Points

Medication: | Dimethyl fumarate (120 mg twice daily)
Pattern: | Hepatocellular (R=36)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4 weeks to ALT elevations, 7-8 weeks to jaundice
Recovery: | Within 1 to 2 months
Other medications: | None reported

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Dimethyl fumarate started (120 mg twice daily
4 weeks | 0 | 284 | | | Drug stopped
8 weeks | 4 weeks | 1256 | 133 | 9.0 | Jaundice and symptoms
| 4.5 weeks | 941 | 123 | 11.6 | Liver biopsy
9 weeks | 5 weeks | 729 | 129 | 15.4
10 weeks | 6 weeks | 342 | 137 | 1.6
15 weeks | 9 weeks | 48 | 74 | 0.4 | Asymptomatic
> 1 year | > 1 year | Normal | Normal | Normal | On glatiramer
Normal Values | | <35 | <104 | <1.2

#### Comment

This patient was found to have serum enzyme elevations four weeks after starting dimethyl fumarate. The aminotransferase were approximately 8 times the upper limit of normal and had been normal when tested before starting the multiple sclerosis agent. The drug was promptly discontinued, but the patient went on to develop clinical symptoms and jaundice and four weeks later had biochemical and histological features of an acute hepatitis. She was symptomatic for several weeks, but ultimately recovered without specific therapy. This was the initial report of clinically apparent liver injury due to dimethyl fumarate which had been associated with a modest rate of serum enzyme elevations during registration trials. This patient was fortunate to have had the drug stopped promptly; a delay may have led to a more severe and consequential course. Most instances of liver injury associated with dimethyl fumarate have arisen during the first 1 to 2 months of therapy and routine monitoring, as was done for this patient, is not unreasonable.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dimethyl Fumarate – Generic, Tecfidera®

Diroximel Fumarate – Vumerity®

Monomethyl Fumarate – Bafiertam®

DRUG CLASS

Multiple Sclerosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dimethyl+Fumarate) (Dimethyl Fumarate)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Diroximel+Fumarate) (Diroximel Fumarate)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Monomethyl+Fumarate) (Monomethyl Fumarate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Dimethyl Fumarate | 624-49-7 | C6-H8-O4
Diroximel Fumarate | 1577222-14-0 | C11-H13-N-O6
Monomethyl Fumarate | 2756-87-8 | C5-H6-O4

## CITED REFERENCES

1 Jüngst C, Kim YJ, Lammert F. Severe drug-induced liver injury related to therapy with dimethyl fumarate. Hepatology 2016; 64: 1367-9.27228386

## ANNOTATED BIBLIOGRAPHY

References updated: 25 September 2025

Abbreviations used: ULN, upper limit of the normal range

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 697-8. (Expert review of hepatotoxicity published in 1999; dimethyl fumarate is not discussed).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013 does not discuss the drugs for multiple sclerosis).
Krensky AM, Azzi JR, Hafler DA. Immunotherapy for multiple sclerosis. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 649-652. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2013/204063Orig1s000MedR.pdf (FDA website with product labels and clinical review of data provided in support of the 2013 approval of dimethyl fumarate as therapy of relapsing-remitting multiple sclerosis in adults, mentions that rates of ALT elevations leading to discontinuation were less than 1% in dimethyl fumarate treated and placebo recipients and there were no serious hepatic adverse events attributed to therapy).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/211855Orig1s000MedR.pdf (FDA website with product labels and clinical review of data provided in support of the 2019 approval of diroximel fumarate as therapy of relapsing multiple sclerosis in adults, mentions that in one study of 118 patients ALT elevations above 3 times ULN arose in 2.5%, but none were above 5 times ULN and none were associated with jaundice or considered a severe adverse event).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/210296Orig1s000MedR.pdf (FDA website with product labels and clinical review of data provided in support of the 2020 approval of monomethyl fumarate as therapy of relapsing multiple sclerosis in adults, states that the basis for approval was demonstration of bioequivalence to dimethyl fumarate and not studies of efficacy or safety; in analyses of multiple open label studies in approximately 200 patients that there were no serious adverse events; no mention of ALT or bilirubin levels or hepatobiliary adverse events).
Mrowietz U, Christophers E, Altmeyer P. Treatment of psoriasis with fumaric acid esters: results of a prospective multicentre study. German Multicentre Study. Br J Dermatol 1998; 138: 456-60. (Open label trial of fumarate esters in 101 patients with psoriasis; major side effects were gastrointestinal complaints [56%] and flushing [31%]; biochemical laboratory results were reported to have not changed). 9580799
Hoefnagel JJ, Thio HB, Willemze R, Bouwes Bavinck JN. Long-term safety aspects of systemic therapy with fumaric acid esters in severe psoriasis. Br J Dermatol 2003; 149: 363-9. (Retrospective review of tolerance of fumarate ester therapy of psoriasis in 66 patients treated for up to 14 years; side effects included flushing [55%], diarrhea [42%], and decrease in lymphocyte counts; ALT elevations occurred in 2 and GGT in 14 patients, but were transient, not associated with jaundice and led to discontinuation in only 2 patients). 12932244
Harries MJ, Chalmers RJ, Griffiths CE. Fumaric acid esters for severe psoriasis: a retrospective review of 58 cases. Br J Dermatol 2005; 153: 549-51. (Retrospective analysis of 58 patients with psoriasis who were treated with fumarate esters; side effects of flushing, diarrhea and abdominal discomfort were common; 4 patients developed liver enzyme abnormalities, prompting discontinuation in 3, but no details provided). 16120141
Schimrigk S, Brune N, Hellwig K, Lukas C, Bellenberg B, Rieks M, Hoffmann V, et al. Oral fumaric acid esters for the treatment of active multiple sclerosis: an open-label, baseline-controlled pilot study. Eur J Neurol 2006; 13: 604-10. (Open label study of fumarate esters in 10 patients with multiple sclerosis; 4 patients developed ALT elevations [less than twice ULN], but all resolved without modification of dose). 16796584
Kappos L, Gold R, Miller DH, Macmanus DG, Havrdova E, Limmroth V, Polman CH, et al.; BG-12 Phase IIb Study Investigators. Efficacy and safety of oral fumarate in patients with relapsing-remitting multiple sclerosis: a multicentre, randomised, double-blind, placebo-controlled phase IIb study. Lancet 2008; 372(9648): 1463-72. (Controlled trial of 3 doses of dimethyl fumarate vs placebo for 24 weeks in 257 adults with relapsing-remitting multiple sclerosis; elevations in serum aminotransferase levels above 3 times the ULN were more common in patients on the highest doses of dimethyl fumarate, but were not accompanied by symptoms or increases in serum bilirubin and all resolved upon discontinuation; no specific details provided). 18970976
Gold R. Oral therapies for multiple sclerosis: a review of agents in phase III development or recently approved. CNS Drugs 2011; 25: 37-52. (Review of oral medications for multiple sclerosis under development including dimethyl fumarate [BG-12], fingolimod, teriflunomide, laquinimod and cladribine; no discussion of hepatotoxicity). 21128693
Fox RJ, Miller DH, Phillips JT, Hutchinson M, Havrdova E, Kita M, Yang M, et al.; CONFIRM Study Investigators. Placebo-controlled phase 3 study of oral BG-12 or glatiramer in multiple sclerosis. N Engl J Med 2012; 367: 1087-97. (Controlled trial of dimethyl fumarate vs glatiramer vs placebo in 1417 patients with relapsing multiple sclerosis; ALT elevations above 3 times ULN occurred in 6% of dimethyl fumarate, 7% of glatiramer and 6% of placebo recipients, and no patient developed jaundice or clinically apparent liver injury). 22992072
Gold R, Kappos L, Arnold DL, Bar-Or A, Giovannoni G, Selmaj K, Tornatore C, et al.; DEFINE Study Investigators. Placebo-controlled phase 3 study of oral BG-12 for relapsing multiple sclerosis. N Engl J Med 2012; 367: 1098-107. (Controlled trial of 2 doses of dimethyl fumarate vs placebo for up to 2 years in 1234 patients with relapsing multiple sclerosis; transient ALT elevations above 3 times ULN occurred in 6% of dimethyl fumarate vs 3% of placebo recipients, but no patient developed jaundice or clinically apparent liver injury). 22992073
Oh J, O'Connor PW. Safety, tolerability, and efficacy of oral therapies for relapsing-remitting multiple sclerosis. CNS Drugs 2013; 27: 591-09. (Review of efficacy and safety or oral agents for multiple sclerosis, including fingolimod, teriflunomide, dimethyl fumarate, laquinimod and cladribine, none of which have raised major issues of hepatotoxicity). 23801528
Pawate S, Bagnato F. Newer agents in the treatment of multiple sclerosis. Neurologist 2015; 19: 104-17. (Summary of the efficacy and safety of new drugs for multiple sclerosis mentions that fingolimod, laquinimod and teriflunomide have been associated with serum enzyme elevations during treatment, but no specifics given). 25888198
English C, Aloi JJ. New FDA-Approved Disease-Modifying Therapies for Multiple Sclerosis. Clin Ther 2015; 37: 691-715. (Systematic review of efficacy and safety of the newer disease modifying therapies of multiple sclerosis lists ALT elevations as adverse events associated with fingolimod, teriflunomide and dimethyl fumarate, but not peginterferon beta or alemtuzumab). 25846320
Dubey D, Kieseier BC, Hartung HP, Hemmer B, Warnke C, Menge T, Miller-Little WA, et al. Dimethyl fumarate in relapsing-remitting multiple sclerosis: rationale, mechanisms of action, pharmacokinetics, efficacy and safety. Expert Rev Neurother 2015; 15: 339-46. (Review of the mechanism of action, pharmacology, efficacy and safety of dimethyl fumarate in multiple sclerosis, mentions that aminotransferase elevations occurred in 25% of patients, but these abnormalities generally resolved and discontinuation was required in <1% of patients; no mention of clinically apparent liver injury). 25800129
Sheremata W, Brown AD, Rammohan KW. Dimethyl fumarate for treating relapsing multiple sclerosis. Expert Opin Drug Saf 2015; 14: 161-70. (Review of the structure, mechanism of action, clinical efficacy and safety of dimethyl fumarate, mentions that the most common side effects are flushing and gastrointestinal complaints [pain, diarrhea and nausea] and that laboratory abnormalities include increase in aminotransferase levels and decrease in lymphocytes; no mention of clinically apparent hepatotoxicity). 25382392
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 [0.8%] were attributed to interferon beta, but none were linked to dimethyl fumarate or other drugs used for multiple sclerosis). 25754159
Jüngst C, Kim YJ, Lammert F. Severe drug-induced liver injury related to therapy with dimethyl fumarate. Hepatology 2016; 64: 1367-9. (26 year old woman developed abnormal liver tests 4 weeks after starting dimethyl fumarate for multiple sclerosis, subsequently developing jaundice despite prompt discontinuation [bilirubin 9.0 mg/dL, ALT 1256 U/L, Alk P 133 U/L, INR 1.6], resolving within 2 months). 27228386
Muñoz MA, Kulick CG, Kortepeter CM, Levin RL, Avigan MI. Liver injury associated with dimethyl fumarate in multiple sclerosis patients. Mult Scler. 2017;23:1947-9. (Among 14 cases of liver injury attributed to dimethyl fumarate reported to the FDA during the first 3 years after its approval, 12 were women, 2 men, ages 25 to 56 years, jaundice in 8, average latency 101 days [4 to 302], mostly hepatocellular, improving with discontinuation, none fatal). 28086032
Filippi M, Bar-Or A, Piehl F, Preziosa P, Solari A, Vukusic S, Rocca MA. Multiple sclerosis. Nat Rev Dis Primers. 2018;4:43.. (Review of the pathogenesis, clinical features, natural history, management and therapy of multiple sclerosis). 30410033
Antonazzo IC, Poluzzi E, Forcesi E, Riise T, Bjornevik K, Baldin E, Muratori L, et al. Liver injury with drugs used for multiple sclerosis: a contemporary analysis of the FDA Adverse Event Reporting System. Mult Scler. 2019;25:1633-1640. PIMD: 30230957. (Among 4873 cases of severe liver injury attributed to agents used to treat multiple sclerosis reported to the FDA’s Adverse Event Reporting System between 2004 and 2016, the most frequently implicated agents were interferon-beta1a [n=2343], natalizumab [n=759], interferon beta1b [535], fingolimod [496], dimethyl fumarate [223], glatimer acetate [212] and teriflunomide [158].
Diebold M, Fischer-Barnicol B, Tsagkas C, Kuhle J, Kappos L, Derfuss T, Décard BF. Hepatitis E virus infections in patients with MS on oral disease-modifying treatment. Neurol Neuroimmunol Neuroinflamm. 2019;6:e594. (Between 2016 and 2019, 4 patients with multiple sclerosis developed unexplained liver test abnormalities which upon testing were found to be acute hepatitis E, including 3 patients on fingolimod and 1 on dimethyl fumarate [3 symptomatic, 2 jaundiced, ALT 180-2545 U/L], all resolved and most could restart the medication without recurrence of liver injury). 31454772
Derfuss T, Mehling M, Papadopoulou A, Bar-Or A, Cohen JA, Kappos L. Advances in oral immunomodulating therapies in relapsing multiple sclerosis. Lancet Neurol. 2020;19:336-347. (Review of relative efficacy and safety of new oral disease modifying agents for multiple sclerosis including monomethyl fumarate, which is claimed to have fewer gastrointestinal adverse effects; no mention of ALT elevations or hepatotoxicity). 32059809
Wynn D, Lategan TW, Sprague TN, Rousseau FS, Fox EJ. Monomethyl fumarate has better gastrointestinal tolerability profile compared with dimethyl fumarate. Mult Scler Relat Disord. 2020;45:102335. (Among 210 adults with relapsing multiple sclerosis treated with dimethyl [240 mg] or monomethyl fumarate [190 mg] daily for 5 weeks, gastrointestinal adverse events were numerically but not statistically less frequent with monomethyl than dimethyl fumarate [52% vs 62%] as were ALT elevations as well [0% vs 2%], but there were no severe adverse events). 32629403
Naismith RT, Wundes A, Ziemssen T, Jasinska E, Freedman MS, Lembo AJ, Selmaj K, et al.; EVOLVE-MS-2 Study Group. Diroximel fumarate demonstrates an improved gastrointestinal tolerability profile compared with dimethyl fumarate in patients with relapsing-remitting multiple sclerosis: results from the randomized, double-blind, phase III EVOLVE-MS-2 Study. CNS Drugs. 2020;34:185-196. (Among 696 patients with relapsing-remitting multiple sclerosis treated with diroximel fumarate for up to 2 years, adverse events arose in 85% but were mostly mild or moderate with discontinuations, because of side effects in only 6.3% and ALT elevations above 3 times ULN in 2.3%, above 5 times ULN in 1% and resulting in discontinuation in only 0.6%, no patient developing ALT elevations and jaundice). 31953790
Naismith RT, Wolinsky JS, Wundes A, LaGanke C, Arnold DL, Obradovic D, Freedman MS, et al. Diroximel fumarate (DRF) in patients with relapsing-remitting multiple sclerosis: Interim safety and efficacy results from the phase 3 EVOLVE-MS-1 study. Mult Scler. 2020;26:1729-1739. (Among 504 patients with relapsing multiple sclerosis treated with either diroximel [DRF] or dimethyl fumarate [DMF] for 5 weeks, gastrointestinal side effects were less frequent with DRF 35% vs 49%, and overall discontinuation rates were lower [1.6% vs 5.6%], while rates of ALT elevations were similar [5.5% vs 3.6%]). 31680631
Ng HS, Kingwell E, Zhu F, Zhang T, Marrie RA, Carruthers R, Tremlett H. Adherence to laboratory monitoring among people taking oral drugs for multiple sclerosis: A Canadian population-based study. Mult Scler. 2021;27:239-249. (Analysis of data from Canadian health records found that liver biochemical tests monitoring was done in a high proportion of patients with multiple sclerosis starting dimethyl fumarate [91% before therapy, 89% during months 1-6, and 89% during months 7-12]). 32141376
Drugs for multiple sclerosis. Med Lett Drugs Ther. 2021;63(1620):42-48. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for multiple sclerosis mentions that dimethyl fumarate can cause hepatotoxicity and that diroximel fumarate provides similar monomethyl fumarate [the active metabolite] exposure and has similar adverse events, except for fewer gastrointestinal side effects). 33976089
Liseno J, Lager B, Miller C, Shankar SL, Mendoza JP, Lewin JB. Multiple sclerosis patients treated with diroximel fumarate in the real-world setting have high rates of persistence and adherence. Neurol Ther. 2021;10:349-360. (Among 160 patients with multiple sclerosis treated with diroximel fumarate, which reportedly has fewer gastrointestinal side effects, for up to 10 months, 89% remained on therapy and gastrointestinal adverse events were uncommon resulting in discontinuation in only 3.8% of patients). 33846959
Nehzat N, Mirmosayyeb O, Barzegar M, Vosoughi R, Fazeli E, Shaygannejad V. Comparable Efficacy and safety of teriflunomide versus dimethyl fumarate for the treatment of relapsing-remitting multiple sclerosis. Neurol Res Int. 2021;2021:6679197.. (Among 159 Iranian patients with relapsing-remitting multiple sclerosis treated with either teriflunomide or dimethyl fumarate the matched cohorts had similar annualized relapse rates and adverse event rates [81% vs 88%] and “liver dysfunction” rates [15% vs 15%] while only 1 patient [who was receiving teriflunomide] discontinued therapy because of “abnormal liver function”). 34336283
Biolato M, Bianco A, Lucchini M, Gasbarrini A, Mirabella M, Grieco A. The disease-modifying therapies of relapsing-remitting multiple sclerosis and liver injury: a narrative review. CNS Drugs. 2021;35:861-880. (Extensive review of the pre- and postmarketing data on hepatotoxicity of disease modifying therapies of relapsing forms of multiple sclerosis, none of which are completely free of the potential of hepatotoxicity, including dimethyl fumarate which was reported to have a high rate of minor aminotransferase elevations but only rare instances of values rising above 5 times ULN in preregistration studies, yet subsequently, cases of clinically apparent liver injury with symptoms and jaundice were reported such that routine monitoring of liver tests especially during the first year of therapy is now recommended). 34319570
Swindell WR, Bojanowski K, Chaudhuri RK. Transcriptomic analysis of fumarate compounds identifies unique effects of isosorbide di-(methyl fumarate) on NRF2, NF-kappaB and IRF1 pathway genes. Pharmaceuticals (Basel). 2022;15:461. (Analysis of gene expression by human fetal astrocytes by in vitro exposure to monomethyl fumarate and diroximel fumarate showed evidence of NRF2 activation and NFκB suppression by both). 35455458
Biolato M, Bianco A, Lucchini M, Gasbarrini A, Mirabella M, Grieco A. The disease-modifying therapies of relapsing-remitting multiple sclerosis and liver injury: a narrative review. CNS Drugs. 2021;35:861-880.. (Extensive review of the frequency and characteristics of hepatic injury associated with different disease modifying drugs for multiple sclerosis, mentions that elevations in serum aminotransferase levels arise in 5% of treated patients but are generally transient and mild, but that rare instances of acute liver injury with autoimmune features have been reported). 34319570
Ng HS, Zhu F, Zhao Y, Yao S, Lu X, Ekuma O, Evans C, Fisk JD, Marrie RA, Tremlett H. Adverse Events associated with disease-modifying drugs for multiple sclerosis: a multiregional population-based study. Neurology. 2024;102:e208006.. (Among 35,894 people from 4 Canadian provinces with multiple sclerosis and available health data there was an increased risk for incident chronic liver disease in patients on teriflunomide and acute liver injury in those on dimethyl fumarate, but rates of acute liver injury on natalizumab were too few [<6 in among 827 patient-years] to calculate risk). 38181306
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. PMID: PIMD: 38992407. (Among 483 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, single instances of liver injury were due to natalizumab and fingolimod but none were attributed to interferon-beta or dimethyl fumarate [personal communication]).

## OTHER REFERENCE LINKS

1. Recent References on Dimethyl Fumarate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Dimethyl+Fumarate+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Dimethyl Fumarate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dimethyl+Fumarate)

3. Recent References on Diroximel Fumarate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Diroximel+Fumarate+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

4. Trials on Diroximel Fumarate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Diroximel+Fumarate)

5. Recent References on Monomethyl Fumarate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Monomethyl+Fumarate+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

6. Trials on Monomethyl Fumarate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Monomethyl+Fumarate)